# Docusate

## OVERVIEW

### Introduction

Docusate is an orally available, over-the-counter laxative and stool softener used to treat or prevent constipation. Docusate has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury with jaundice.

### Background

Docusate (dok’ ue sate) is a stool softener and surfactant previously known as dioctyl sodium [or calcium] sulfosuccinate (DSS). Docusate is commonly used to treat or prevent constipation and to promote bowel regularity in hospitalized, bed-bound or immobilized persons. Docusate salts are thought to act as detergents, reducing surface tension of liquids and fatty substances in the intestine, thereby softening stool consistency. The efficacy of docusate in treatment and prevention of constipation has not been well documented. However, extensive experience with its use has documented its safety and tolerability. Docusate has been in use in the U.S. since the 1950s and current indications are for treatment and prevention of constipation. Docusate is available without prescription in capsules of 50, 100, 240 and 250 mg generically and under various brand names such as Colace, Doxidan, Regulex, Silace and Surfak. A liquid formulation for oral use is also available. The typical oral dose is 50 to 300 mg daily until bowel movements are normal. Common side effects include diarrhea, abdominal cramping, nausea, bitter taste and dizziness.

### Hepatotoxicity

Docusate has not been linked to elevations in serum enzyme levels during treatment, although there have been few published studies of its effects of liver tests. There have been no cases of clinically apparent liver injury attributable to docusate published in the literature and, thus, significant liver injury from docusate must be exceedingly rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Docusate is metabolized by the liver and undergoes extensive first-pass metabolism to both active and inactive metabolites. Despite its hepatic metabolism and high level of plasma protein binding, it has not been implicated in causing drug-drug interactions. The lack of reported cases of liver injury due to docusate may be due to the low doses of typical therapy.

Drug Class: Gastrointestinal Agents, Cathartics and Laxatives

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Docusate – Generic, Colace®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Docusate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Docusate | 10041-19-7 | C20-H38-O7-S | Docusate chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 09 January 2018

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 does not discuss docusate).
Sharkey KA, Wallace JL. Treatment of disorders of bowel motility and water flux: anti-emetics; agents used in biliary and pancreatic disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1323-50. (Textbook of pharmacology and therapeutics).
Ramkumar D, Rao SS. Efficacy and safety of traditional medical therapies or chronic constipation: systematic review. Am J Gastroenterol 2005; 100: 936-71. (Systematic review of the literature for controlled trials of traditional therapies for constipation reported "a paucity of trials for many commonly used agents", including bisacodyl and docusate). 15784043
Hurdon V, Viola R, Schroder C. How useful is docusate in patients at risk for constipation? A systematic review of the evidence in the chronically ill. J Pain Symptom Manage 2000; 19: 130-6. (Systematic review of efficacy of docusate for constipation in chronically ill patients identified four studies of docusate vs placebo for 20 to 26 days in doses of 60-480 mg daily, all showing slight effect on stool frequency, but only one documenting normal laboratory test results on treatment). 10699540
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no cases were attributed to laxatives). 18955056
Mueller-Lissner SA, Wald A. Constipation in adults. Clin Evid (Online) 2010; 2010. pii: 0413. (Review of evidence of efficacy of conventional therapies of constipation). 21418672
Ruston T, Hunter K, Cummings G, Lazarescu A. Efficacy and side-effect profiles of lactulose, docusate sodium, and sennosides compared to PEG in opioid-induced constipation: a systematic review. Can Oncol Nurs J 2013; 23: 236-46. (Systematic review of literature on controlled trials of docusate in opioid induced constipation found no articles that met the authors' criteria for medical evidence of efficacy; no discussion of safety). 24428006
Tarumi Y, Wilson MP, Szafran O, Spooner GR. Randomized, double-blind, placebo-controlled trial of oral docusate in the management of constipation in hospice patients. J Pain Symptom Manage 2013; 45: 2-13. (In 74 hospice patients treated with docusate or placebo for 10 days, there were no differences in stool frequency or consistency between the two groups; adverse events were not mentioned). 22889861
Müller-Lissner S. Pharmacokinetic and pharmacodynamic considerations for the current chronic constipation treatments. Expert Opin Drug Metab Toxicol 2013; 9: 391-401. (Review of the pharmacology, efficacy and safety of medications for constipation mentions that docusate is commonly used, but "there is apparently no evidence at all that it is better than placebo"; no mention of side effects). 23425050
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to laxatives). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to docusate or other over-the-counter laxatives). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Docusate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Docusate+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Docusate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Docusate)